# Carisoprodol

## OVERVIEW

### Introduction

Carisoprodol is a centrally acting muscle relaxant that has been in use for more than fifty years without significant evidence for causing hepatic injury.

### Background

Carisoprodol (kar eye" soe proe' dol) is a carbamate derivative similar to meprobamate. Its mechanism of action as a muscle relaxant is unknown, but it is a sedative and may act centrally by modifying perception of pain without affecting pain reflexes. Carisoprodol is recommended for treatment of acute, painful disorders of the musculoskeletal system. Carisoprodol is available in 250 and 350 mg tablets in generic formulations and under the trade names of Soma, Carisoma, Sodol and Vanadom. Fixed combinations of carisoprodol with aspirin or codeine are also available. The recommended adult dosage is 250 to 350 mg three to four times daily for 2 to 3 weeks. Carisoprodol was approved for use in the United States in 1959 and is widely used with more than 10 million prescriptions filled yearly. It is available by prescription only and is classified as a Schedule IV agent, meaning that it has low potential for abuse and physical or psychological dependence and has an accepted medical usefulness. Common side effects include dizziness, drowsiness and headache. Overdose can cause progressive obtundation, coma, neuromuscular rigidity, myoclonus and seizures.

### Hepatotoxicity

There have been no adequate prospective studies demonstrating the rates of aminotransferase elevations on carisoprodol therapy or convincing case reports of clinically apparent liver injury due to carisoprodol. Thus, the hepatotoxic potential of this medication is low. It has been increasingly reported as a substance of abuse, taken in higher than recommended doses.

Likelihood score: E (Unlikely cause of clinically apparent liver injury).

Drug Class: Muscle Relaxants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Carisoprodol – Generic, Soma®

DRUG CLASS

Autonomic Agents: Muscle Relaxants, Central

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=carisoprodol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Carisoprodol | 78-44-4 | C12-H24-N2-O4 | Carisoprodol chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2017

Zimmerman HJ. Muscle spasmolytics. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 544-45. (Expert review of hepatotoxicity published in 1999; discusses dantrolene, chlorzoxazone and baclofen, but not carisoprodol).
Hibbs RE, Zambon AC. Agents acting at the neuromuscular junction and autonomic ganglia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s The pharmacological basis of therapeutics, 12th ed. New York: McGraw-Hill, 2011. p. 255-76. (Textbook of pharmacology and therapeutics).
Goldberg D. Carisoprodol toxicity. Military Med 1969; 134: 597-601. (Case report of patient with intentional carisoprodol overdose presented with twitching and coma requiring intubation, but ultimately recovered; no mention of liver abnormalities). 4979454
Roth BA, Vinson DR, Kim S. Carisoprodol-induced myoclonic encephalopathy. J Toxicol Clin Toxicol 1998; 36: 609-12. (Case report of patient with carisoprodol overdose who developed coma, but had no liver abnormalities). 9776967
Chou R, Peterson K, Helfand M. Comparative efficacy and safety of skeletal muscle relaxants for spasticity and musculoskeletal conditions: a systematic review. J Pain Symptom Manage 2004; 28: 140-75. (Thorough review of the pharmacology, efficacy and side effects of the muscle relaxants). 15276195
Toth PP, Urtis J. Commonly used muscle relaxant therapies for acute low back pain: a review of carisoprodol, cyclobenzaprine hydrochloride, and metaxalone. Clin Ther 2004; 26: 1355-67. (A review of safety and efficacy of muscle relaxants metnions that the major adverse effects of carisoprodol are drowsiness, dizziness, vertigo, ataxia, tremor, irritability and headache, and that its potential for abuse and dependence limit its usefulness for rehabilation). 15530999
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to a specific muscle relaxant). 15390328
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to muscle relaxants). 20949552
Reeves RR, Burke RS, Kose S. Carisoprodol: update on abuse potential and legal status. South Med J 2012; 105: 619-23. (Review of the abuse of carisoprodol and its classification as a schedule IV class agent). 23128807
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to carisoprodol or other muscle relaxants). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.7%] were attributed to muscle relaxants [2 to dantrolene, and 1 each to baclofen, metaxalone and tizanidine], but none were attributed to carisoprodol). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Carisoprodol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Carisoprodol/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/12/01/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Carisoprodol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Carisoprodol)